# Dinutuximab

## OVERVIEW

### Introduction

Dinutuximab is a recombinant chimeric monoclonal antibody to GD2 which is used as an anticancer agent in combination with other antineoplastic agents in the treatment of neuroblastoma. Transient asymptomatic elevations in serum aminotransferase levels are common during dinutuximab therapy, but it has not been linked to instances of clinically apparent liver injury.

### Background

Dinutuximab (din" ue tux' i mab) is a mouse-human chimeric monoclonal IgG1 antibody to disialoganglioside (GD2), a cell surface glycolipid that is present in low concentrations on skin, neural or peripheral nerve cells and is overexpressed on neuroblastoma cells. Engagement of dinutuximab with GD2 triggers antibody dependent cell cytotoxicity. Cytotoxicity of dinutuximab is increased by coadministration of granulocyte-macrophage colony stimulating factor (GM-CSF) and interleukin 2 (IL2) because of their effects on neutrophils, macrophages and immune effector cells, for which reason dinutuximab is usually combined with these cytokines. Dinutuximab was approved for use in neuroblastoma in the United States in 2015. Current indications are for its administration with IL2 or GM-CSF added to standard isotretinoin therapy of high risk pediatric patients with neuroblastoma. Dinutuximab is available in liquid solution in single use vials of 17.5 mg in 5 mL (3.5 mg/mL) under the brand name Unituxin. Dinutuximab is given by slow intravenous infusion (over 10 hours) in a dose of 17.5 mg/m^2^ daily for 4 consecutive days, repeated in up to 5 cycles. Premedication with hydration, diphenhydramine, acetaminophen and a potent analgesic [such as morphine] is recommended. Adverse side effects of the combination immunotherapy are frequent and can be severe. These side effects include infusion reactions, nausea and vomiting, rash, hypotension, capillary leak syndrome, neuropathic pain and peripheral neuropathy. Less common, but potentially severe side effects include severe hypersensitivity reactions, neurologic and ophthalmologic toxicities, transverse myelitis, reversible posterior leukoencephalopathy syndrome, severe infections, bone marrow suppression, electrolyte abnormalities and embryo-fetal toxicity.

### Hepatotoxicity

Serum aminotransferase elevations are common during dinutuximab therapy occurring in at least 50% of patients, but the abnormalities are usually transient and asymptomatic, resolving spontaneously before the time for the next cycle of infusions. ALT elevations above 5 times the upper limit of normal occurred in 8% to 23% of patients in preregistration trials. However, clinically apparent liver injury with jaundice has not been described in clinical trials or case series on the use of dinutuximab in children with neuroblastoma.

Likelihood score: E* (unproven but suspected cause of clinically apparent acute liver injury).

### Mechanism of Injury

The mechanism of liver injury caused by dinutuximab is not known. It is a recombinant protein and unlikely to be inherently hepatoxic, but may trigger liver injury by engagement of low levels of GD2 on hepatocytes or sinusoidal cells, triggering cell injury. The aminotransferase elevations with dinutuximab do not appear to be related to the frequent hypersensitivity infusion reactions, which may be due in part to reactions to the chimeric antibody.

### Outcome and Management

Patients with neuroblastoma receiving dinutuximab therapy require careful monitoring of both hematologic and clinical chemistry test results. Serum aminotransferase elevations that persist or rise above 5 times ULN should lead to delay in subsequent infusions until the abnormalities resolve. The appearance of symptoms of liver injury or jaundice should lead to discontinuation.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dinutuximab – Unituxin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dinutuximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Dinutuximab | 1363687-32-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 03 January 2018

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; no specific discussion of dinutuximab).
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Yu AL, Uttenreuther-Fischer MM, Huang CS, Tsui CC, Gillies SD, Reisfeld RA, Kung FH. Phase I trial of a human-mouse chimeric anti-disialoganglioside monoclonal antibody ch14.18 in patients with refractory neuroblastoma and osteosarcoma. J Clin Oncol 1998; 16: 2169-80. (Among 10 children with recurrent, refractory neuroblastoma and 1 with osteosarcoma treated with dinutuximab [10, 20, 50, 100 or 200 mg/m2], half had an objective response while side effects were common including infusion reactions, neuropathic pain, tachycardia, hypertension, fever, rash; transient ALT elevations occurred in 3 patients and were recurrent with subsequent infusions in one [peak ALT levels 94-424 U/L]). 9626218
Albertini MR, Hank JA, Schiller JH, Khorsand M, Borchert AA, Gan J, Bechhofer R, et al. Phase IB trial of chimeric antidisialoganglioside antibody plus interleukin 2 for melanoma patients. Clin Cancer Res 1997; 3: 1277-88. (Among 24 patients with advanced melanoma treated with dinutuximab and IL2, two patients had an objective response but adverse events were frequent, most attributable to IL2, but also with frequent infusion reactions and several severe allergic reactions). 9815810
Ozkaynak MF, Sondel PM, Krailo MD, Gan J, Javorsky B, Reisfeld RA, Matthay KK, et al. Phase I study of chimeric human/murine anti-ganglioside G(D2) monoclonal antibody (ch14.18) with granulocyte-macrophage colony-stimulating factor in children with neuroblastoma immediately after hematopoietic stem-cell transplantation: a Children's Cancer Group Study. J Clin Oncol. 2000; 18: 4077-85. (Among 19 children with neuroblastoma treated with 79 courses of dinutuximab and GM-CSF after hematopoietic cell transplant, toxicities included pain, fever, nausea and vomiting, rash, hypotension, capillary leak syndrome and neurotoxicity; “transient and insignificant AST/ALT elevations were observed”). 11118469
Simon T, Hero B, Faldum A, Handgretinger R, Schrappe M, Niethammer D, Berthold F. Consolidation treatment with chimeric anti-GD2-antibody ch14.18 in children older than 1 year with metastatic neuroblastoma. J Clin Oncol 2004; 22: 3549-57. (Among 334 patients enrolled in a German cooperative study of therapies of neuroblastoma of whom 166 received dinutuximab, event free survival was not different between those who had and had not received dinutuximab, while side effects of the treatment were frequent; ALT elevations occurred during 5% of cycles and in 12.8% of patients who received dinutuximab). 15337804
Yu AL, Gilman AL, Ozkaynak MF, London WB, Kreissman SG, Chen HX, Smith M, et al.; Children's Oncology Group. Anti-GD2 antibody with GM-CSF, interleukin-2, and isotretinoin for neuroblastoma. N Engl J Med 2010; 363: 1324-34. (Among 222 patients with neuroblastoma treated with isoretinoin and dinutuximab [with GM-CSF and IL2] or placebo after induction therapy and hematopoietic cell transplant, event free and overall survival were greater with the addition of immunotherapy but adverse events were more common, including pain, hypotension, capillary leak syndrome and hypersensitivity reactions; ALT elevations above 5 times ULN occurred in 23% [vs 3% with isoretinoin alone]). 20879881
Simon T, Hero B, Faldum A, Handgretinger R, Schrappe M, Klingebiel T, Berthold F. Long term outcome of high-risk neuroblastoma patients after immunotherapy with antibody ch14.18 or oral metronomic chemotherapy. BMC Cancer 2011; 11: 21. (Long term follow up of 334 patients with neuroblastoma described previously [Simon 2004] found an improved long term overall survival rate associated with dinutuximab; no discussion of adverse side effects). 21244693
Ploessl C, Pan A, Maples KT, Lowe DK. Dinutuximab: An anti-GD2 monoclonal antibody for high-risk neuroblastoma. Ann Pharmacother 2016; 50: 416-22. (Review of the pharmacology, mechanism of action, clinical efficacy and safety of dinutuximab discusses its adverse events in detail and mentions that ALT elevations arise in 56% of patients, but does not mention clinical apparent hepatotoxicity). 26917818
In brief: Dinutuximab (Unituxin) for high-risk neuroblastoma. Med Lett Drugs Ther 2016; 58 (1491): e48. (Brief review of the mechanism of action, clinical efficacy, safety and costs of dinutuximab shortly after its approval for use in the US; mentions severe adverse events such as infusion reactions, pain, peripheral neuropathy, capillary leak syndrome, visual disturbances, hemolytic uremic syndrome, but does not mention hepatotoxicity or ALT elevations). 27027692
Ding YY, Panzer J, Maris JM, Castañeda A, Gomez-Chiari M, Mora J. Transverse myelitis as an unexpected complication following treatment with dinutuximab in pediatric patients with high-risk neuroblastoma: a case series. Pediatr Blood Cancer 2018; 65. Epub 2017 Jul 27. (Three children with neuroblastoma developed lower extremity weakness, numbness and tingling progressing to paralysis [two with bladder and anal sphincter involvement], with transverse myelitis shown by MR imaging shortly after a second course of dinutuximab, recovering symptomatically and radiologically with corticosteroid therapy; no mention of liver injury or ALT elevations). 28748630

## OTHER REFERENCE LINKS

1. Recent References on Dinutuximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Dinutuximab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Dinutuximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dinutuximab)